# Ticagrelor

## OVERVIEW

### Introduction

Ticagrelor is an oral antiplatelet drug that is used with low dose aspirin to decrease the risk of myocardial infarction and stroke in patients with acute coronary syndromes. Ticagrelor has been linked to rare instances of hypersensitivity reactions accompanied by mild liver injury.

### Background

Ticagrelor (tye ka' grel or) is a non-thienopyridine, reversible inhibitor of adenosine diphosphate (ADP) receptors (P2Y 12) on platelets and is used to decrease the risk of recurrent coronary thromboses in patients who undergo interventions during an acute coronary syndrome. Activated platelets release ADP which binds to ADP platelet receptors, causing activation of intracellular glycoprotein IIb/IIIA complex which triggers platelet adherence and aggregation. The aggregation of platelets plays an important role in the growth of atheromatous plaques, which can lead to coronary, cerebral and peripheral arterial occlusions. In clinical trials, ticagrelor therapy during acute coronary events (unstable angina and myocardial infarction) has been shown to decrease the frequency of recurrence of myocardial infarction and stent thrombosis. Ticagrelor was approved for use in the United States in 2011 and has been used in limited numbers of patients for a limited time only. Current indications are reduction of recurrent cardiovascular events in patients with acute coronary syndromes. Ticagrelor is available in 90 mg tablets under the commercial name Brilinta. The usual maintenance dose is 90 mg twice daily in combination with daily low dose aspirin (<100 mg). Side effects are not common, but can include bleeding (12%), dyspnea (14%), headaches, nausea, diarrhea, hypotension and hypersensitivity reactions. Rare but potentially severe adverse reactions include severe bleeding, rhabdomyolysis, complications of drug-drug interactions, angioedema and hypersensitivity reactions.

### Hepatotoxicity

In several large clinical trials, ticagrelor was not associated with serum enzyme elevations during therapy and no instances of clinically apparent liver injury were reported. While there have been isolated reports of transient and mild serum enzyme elevations during ticagrelor therapy, these have been short lived and asymptomatic. In addition, since marketing and release, there have been no reports of isolated clinically apparent liver injury or jaundice associated with ticagrelor therapy and hepatotoxicity is not mentioned in the product label. On the other hand, there have been several reports of jaundice and liver injury associated with rhabdomyolysis and with thrombotic thrombocytopenic purpura that represented secondary effects of these severe adverse events. Thus, significant liver injury due to ticagrelor occurs but has occurred largely in association with other life-threatening complications.

Likelihood score: D (possible rare cause of liver injury due to complications of severe allergic reactions or drug-drug interactions).

### Mechanism of Injury

Ticagrelor, unlike clopidogrel, does not require metabolic activation for its antiplatelet effects. Ticagrelor is metabolized in the liver predominantly via CYP 3A4 and it should be used with caution in patients taking CYP 3A4 inhibitors (such as ketoconazole, clarithromycin, atazanavir and nefazodone), which can increase serum levels, or CYP 3A4 inducers (such as rifampin, dexamethasone and phenytoin) which can decrease drug levels.

### Outcome and Management

There is little evidence that ticagrelor can cause liver injury or has any cross sensitivity to other antiplatelet agents, so that switching from clopidogrel or prasugrel after clinically apparent liver injury is probably safe.

Drug Class: Antithrombotic Agents, Antiplatelet Agents

Other Drugs in the Subclass, Antiplatelet Agents: Aspirin, Cangrelor, Clopidogrel, Dipyridamole, Prasugrel, Ticlopidine, Vorapaxar

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ticagrelor – Brilinta®

DRUG CLASS

Antithrombotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ticagrelor)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ticagrelor | 274693-27-5 | C23-H28-F2-N6-O4-S

## ANNOTATED BIBLIOGRAPHY

References updated: 25 September 2020

Zimmerman HJ. Platelet aggregation inhibitors. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 641-3. (Textbook of hepatotoxicity published in 1999; ticlopidine, but not clopidogrel, prasugrel or ticagrelor is discussed).
De Marzio DH, Navarro VJ. Antiplatelet agents. Hepatotoxicity of cardiovascular and antidiabetic drugs: antihypertensives. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 527-8. (Review of hepatotoxicity of antiplatelet drugs discusses ticlopidine, clopidogrel and prasugrel, but does not mention ticagrelor).
Hogg K, Weitz JI. Blood coagulation and anticoagulant, fibrinolytic, and antiplatelet drugs. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 849-76. (Textbook of pharmacology and therapeutics).
Husted S, Emanuelsson H, Heptinstall S, Sandset PM, Wickens M, Peters G. (2006). Pharmacodynamics, pharmacokinetics, and safety of the oral reversible P2Y12 antagonist AZD6140 with aspirin in patients with atherosclerosis: a double-blind comparison to clopidogrel with aspirin. Eur Heart J. (Among 200 patients with atherosclerosis treated with one of 4 doses of ticagrelor or clopidogrel for 28 days, inhibition of platelet aggregation was greater with higher doses of ticagrelor and the most common adverse events were bleeding, dyspnea, dizziness and headache; "no notable time- or treatment-related changes in any ... clinical chemistry parameters ... were observed").
Cannon CP, Husted S, Harrington RA, Scirica BM, Emanuelsson H, Peters G, Storey RF. (2007). DISPERSE-2 Investigators. Safety, tolerability, and initial efficacy of AZD6140, the first reversible oral adenosine diphosphate receptor antagonist, compared with clopidogrel, in patients with non-ST-segment elevation acute coronary syndrome: primary results of the DISPERSE-2 trial. J Am Coll Cardiol. (Among 990 patients with an acute coronary syndrome treated with one of 2 doses of ticagrelor or clopidogrel for 4-12 weeks, bleeding episodes were similar in the three groups [9.8% and 8.0% vs 8.1%]; no mention of ALT elevations or hepatotoxicity).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to antiplatelet agents).
Wallentin L, Becker RC, Budaj A, Cannon CP, Emanuelsson H, Held C, Horrow J, et al. (2009). PLATO Investigators. Ticagrelor versus clopidogrel in patients with acute coronary syndromes. N Engl J Med. (Among 18,624 patients with acute coronary syndrome treated with ticagrelor or clopidogrel, deaths from vascular cases within 12 months were less with ticagrelor [9.8% vs 11.7%], while major bleeding rates were similar [11.6% vs 11.2%]; no mention of hepatotoxicity or ALT elevations).
Mohammad RA, Goldberg T, Dorsch MP, Cheng JW. (2010). Antiplatelet therapy after placement of a drug-eluting stent: a review of efficacy and safety studies. Clin Ther. (Systematic review of studies of antiplatelet therapy after coronary stenting discussed bleeding complications only, no mention of ALT elevations or hepatotoxicity).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were due to antiplatelet medications).
Anderson SD, Shah NK, Yim J, Epstein BJ. (2010). Efficacy and safety of ticagrelor: a reversible P2Y12 receptor antagonist. Ann Pharmacother. (Systematic review of efficacy and safety of ticagrelor is associated with "no significant changes in laboratory values", with the exception of uric acid).
Held C, Asenblad N, Bassand JP, Becker RC, Cannon CP, Claeys MJ, Harrington RA, et al. (2011). Ticagrelor versus clopidogrel in patients with acute coronary syndromes undergoing coronary artery bypass surgery: results from the PLATO (Platelet Inhibition and Patient Outcomes) trial. J Am Coll Cardiol. (Subgroup analysis of 1261 patients who underwent coronary artery bypass grafting and were treated with ticagrelor or clopidogrel; no discussion of ALT elevations or hepatotoxicity).
James SK, Roe MT, Cannon CP, Cornel JH, Horrow J, Husted S, Katus H, et al., PLATO Study Group. (2011). Ticagrelor versus clopidogrel in patients with acute coronary syndromes intended for non-invasive management: substudy from prospective randomised PLATelet inhibition and patient Outcomes (PLATO) trial. BMJ. (Among 5216 patients with acute coronary syndrome treated with ticagrelor or clopidogrel with a planned noninvasive treatment, cardiovascular death was lower with ticagrelor [12% vs 14.3%], while major bleeding episodes were greater [11.9% vs 10.3%]; no mention of ALT elevations or other adverse events).
Butler K, Teng R. (2011). Pharmacokinetics, pharmacodynamics, and safety of ticagrelor in volunteers with mild hepatic impairment. J Clin Pharmacol. (Pharmacokinetic study in 20 volunteers, 10 with compensated cirrhosis, found minimally higher exposure after a single dose of ticagrelor in patients with liver disease, but not enough to recommend dose adjustment; no side effects or worsening of liver chemistry results).
(2011). Ticagrelor (Brilinta)--better than clopidogrel (Plavix)?. Med Lett Drugs Ther. (Concise review of the pharmacology, efficacy and safety of ticagrelor shortly after its approval in the US mentions side effects of bleeding, dyspnea, bradyarrhythmias and increases in uric acid and creatinine [effects probably related to stimulation of adenosine receptors]; no mention of ALT elevations or hepatotoxicity).
(2011). Antithrombotic drugs. Treat Guidel Med Lett. (Guidelines on use of antiplatelet agents including aspirin, clopidogrel, prasugrel and ticagrelor mentions that ticagrelor was found to be more effective than clopidogrel in one study without an increased rate of bleeding; no mention of other side effects, ALT elevations or hepatotoxicity).
Li H, Butler K, Yang L, Yang Z, Teng R. (2012). Pharmacokinetics and tolerability of single and multiple doses of ticagrelor in healthy Chinese subjects: an open-label, sequential, two-cohort, single-centre study. Clin Drug Investig. (In a pharmacokinetic study of ticagrelor in 26 healthy volunteers, two patients developed asymptomatic serum ALT elevations [1.25 and 3 times ULN] without change in bilirubin or alkaline phosphatase within 3 days of starting ticagrelor and lasting for 10 days after stopping).
Htun WW, Steinhubl SR. (2013). Ticagrelor: the first novel reversible P2Y(12) inhibitor. Expert Opin Pharmacother. (Review of pharmacology, efficacy and safety of ticagrelor in comparison to other antiplatelet agents; no mention of hepatotoxicity or ALT elevations during therapy).
DiNicolantonio JJ, Serebruany VL. (2013). Comparing the safety of ticagrelor versus clopidogrel: insights from the FDA reports. Ther Adv Cardiovasc Dis. (The FDA analysis of trials of ticagrelor reported that patients with preexisting liver disease were more likely to have serious adverse events on ticagrelor than clopidogrel, including death [3.1% vs 0.9%] and major bleeds [11.2% vs 8.7%], the reasons for which were not clear).
Lindholm D, Varenhorst C, Cannon CP, Harrington RA, Himmelmann A, Maya J, Husted S, et al. (2014). Ticagrelor vs. clopidogrel in patients with non-ST-elevation acute coronary syndrome with or without revascularization: results from the PLATO trial. Eur Heart J. (Retrospective analysis of data from the PLATO trial of ticagrelor vs clopidogrel in 18,624 patients with acute coronary syndrome found similar rates of bleeding with both agents; no mention of ALT elevations or hepatotoxicity).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to ticagrelor).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, two were attributed to antithrombotic agents, one to prasugrel and one to dalteparin; none were due to ticagrelor).
Banakh I, Haji K, Kung R, Gupta S, Tiruvoipati R. (2017). Severe rhabdomyolysis due to presumed drug interactions between atorvastatin with amlodipine and ticagrelor. Case Rep Crit Care. (74 year old woman developed rhabdomyolysis 2 months after starting ticagrelor having been on atorvastatin for years with complications of septic shock, renal failure and acute hepatic necrosis [bilirubin 3.1 to 9.8 mg/dL, 746 to 1605 U/L, Alk P 260 to 325 U/L, INR 1.8 to 2.0, CPK >90,000 IU/L], with prolonged ICU stay but ultimate resolution of renal and liver abnormalities).
Bellosta S, Corsini A. (2018). Statin drug interactions and related adverse reactions: an update. Expert Opin Drug Saf. (Summary and review of drug-drug interactions including ticagrelor, a CYP3A4 and P-pg substrate and weak inhibitor which can cause an increase in atorvastatin plasma levels).
Wang X, Zhang S, Li L, Hua J, Zhu L, Li L, Zhang G. (2018). Ticagrelor-induced thrombotic thrombocytopenic purpura: A case report and review of the literature. Medicine (Baltimore). (87 year old man with a history of acute myocardial infarction developed thrombotic thrombocytopenic purpura 2 months after starting ticagrelor [platelets 3,000, hematocrit 22.3%, bilirubin 16.0 mg/dL, ALT 3947 U/L, Alk P 59 U/L, protime 26.3 sec], with spontaneous improvement but recurrence on restarting ticagrelor leading to multiorgan failure and death).
Schüpke S, Neumann FJ, Menichelli M, Mayer K, Bernlochner I, Wöhrle J. (2019). Richardt Get al.; ISAR-REACT 5 Trial Investigators. Ticagrelor or prasugrel in patients with acute coronary syndromes. N Engl J Med. (Among 4018 patients with acute coronary syndromes treated with ticagrelor or prasugrel for one year, major cardiovascular events were less with prasugrel [6.9% vs 9.3%], but major bleeding event rates were similar [4.8% vs 5.4%]; no mention of ALT elevations or hepatotoxicity).
Navarese EP, Khan SU, Kołodziejczak M, Kubica J, Buccheri S, Cannon CP, Gurbel PA, De Servi S, Budaj A, Bartorelli A, Trabattoni D, Ohman EM, Wallentin L, Roe MT, James S. (2020). Comparative efficacy and safety of oral P2Y inhibitors in acute coronary syndrome: network meta-analysis of 52 816 patients from 12 randomized trials. Circulation. (Metaanalysis of 12 randomized controlled trials in 52,816 patients comparing 3 antiplatelet agents found that prasugrel and ticagrelor had lower rates of cardiovascular mortality and stent thrombosis than clopidogrel, but had higher rates of major bleeding episodes; no mention of ALT elevations or hepatotoxicity).
Tarantini G, Mojoli M, Varbella F, Caporale R, Rigattieri S, Andò G, Cirillo P, et al.; DUBIUS Investigators, on behalf of the Italian Society of Interventional Cardiology (SICI-GISE). Timing of oral P2Y inhibitor administration in non-ST elevation acute coronary syndrome. J Am Coll Cardiol 2020: S0735-1097(20)36444-5. Epub ahead of print. (Among 1449 patients undergoing coronary angiography treated with prasugrel or ticagrelor, rates of a combined clinical efficacy endpoint were similar in the two groups; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Ticagrelor: from PubMed.gov (http://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ticagrelor/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Ticagrelor: from ClinicalTrials.gov (http://clinicaltrials.gov/ct2/results?term=Ticagrelor)